# Quizartinib

## OVERVIEW

### Introduction

Quizartinib is an orally administered receptor tyrosine kinase FLT3 inhibitor that is used in combination with other cancer chemotherapeutic agents to treat adults with acute myelogenous leukemia who are positive for FLT3 internal tandem duplication. Quizartinib is associated with a high rate of liver enzyme elevations during therapy, but a similar rate occurs with comparator arms of chemotherapy, and it has not been shown to cause clinically apparent drug induced liver injury.

### Background

Quizartinib (kwiz ar’ ti nib) is an orally available small molecule inhibitor of the receptor tyrosine kinase FLT3 that is used in combination with other chemotherapeutic agents to treat patients with acute myelogenous leukemia (AML) who have mutations in FLT3. AML is the most common cause of acute leukemia in adults, and at least 30% of patients have FLT3 mutations. The FLT3-internal tandem duplication mutation is associated with aggressive disease and poor response rates to standard chemotherapeutic regimens. Quizartinib is one of several inhibitors of FLT mutations and has special activity against the FLT3-internal tandem mutation. Quizartinib was shown to improve overall survival when combined with standard chemotherapy in both newly diagnosed and relapsed or refractory cases of AML with the FLT3-internal tandem mutation. Quizartinib was approved as therapy for adults with newly diagnosed AML with a FLT3 internal tandem duplication in 2023. It is given in combination with standard induction and consolidation chemotherapy and continued as a single agent for maintenance after consolidation. Quizartinib is available in tablets of 17.7 and 26.5 mg under the brand name Vanflyta. The recommended dose regimen varies by treatment phase from 26.5 to 53 mg once daily for different numbers of days in the 28-day cycle. Adverse events include febrile neutropenia, pneumonia, sepsis, diarrhea, nausea, abdominal pain, mucositis, headache, and respiratory tract infections. Laboratory abnormalities include decrease in neutrophils, lymphocytes, potassium, albumin, phosphorus, and magnesium and increases in alkaline phosphatase and creatine phosphokinase. Severe adverse events include QT interval prolongation, febrile neutropenia, sepsis, and embryo-fetal toxicity. Quizartinib should only be administered by health care workers with experience and expertise in managing acute leukemia, cancer chemotherapy, and their complications. Quizartinib is available only through a Risk Evaluation and Mitigation Strategy (REMS) program that requires careful monitoring for and attention to prolongation of the QT interval.

### Hepatotoxicity

In the prelicensure clinical trials of quizartinib in patients with AML, ALT elevations were arose in 10% to 16% of patients and were above 5 times the upper limit of normal (ULN) in 1% to 3%. However, similar rates were reported in subjects receiving chemotherapy without quizartinib and in most instances the elevations were transient, asymptomatic, and not associated with elevations in serum bilirubin. Intermittent elevations in liver enzymes are not uncommon in patients with untreated AML due to bacterial, viral and opportunistic infections. In the registration trials of quizartinib there were uncommon instances of acute liver injury and hepatic failure, but all were attributable to other comorbidities and factors (multiorgan failure), and none were considered due to quizartinib. Since its approval in the United States, there have been no reported cases of clinically apparent liver injury associated with quizartinib therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of serum aminotransferase elevations from quizartinib is unknown. Quizartinib is metabolized by the cytochrome P450 system, predominantly by CYP 3A4 and is susceptible to drug-drug interactions with inducers or inhibitors of the drug metabolizing enzyme which are best avoided during chemotherapy with its use.

### Outcome and Management

The product label for quizartinib does not recommend routine monitoring of liver laboratory tests during therapy. Serum aminotransferase elevations above 5 times the upper limit of normal (if detected) should lead a search for alternative causes of liver enzyme elevations and, if none are found, to dose reduction or temporary cessation of treatment with careful monitoring. Cross sensitivity to liver injury has not been described with the other FLT kinase inhibitors.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Other FLT3 Inhibitors: Gilteritinib, Midostaurin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Quizartinib – Vanflyta®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Quizartinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Quizartinib | 950769-58-1 | C29-H32-N6-O4-S

## ANNOTATED BIBLIOGRAPHY

References updated: 21 July 2024

Abbreviations: AML, acute myelogenous leukemia; ULN, upper limit of normal.

Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. Integrated Review. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2023/216993Orig1s000MultidisciplineR.pdf (FDA website with initial multidiscipline clinical review of the safety and efficacy of quizartinib mentions that ALT elevations arose in 16% of recipients [vs 10% on placebo], but that alternative causes accounted for most abnormalities and all improved without dose modification or discontinuation and that there were no cases of hepatic failure or toxic hepatitis).
Cortes J, Perl AE, Döhner H, Kantarjian H, Martinelli G, Kovacsovics T, Rousselot P, et al. Quizartinib, an FLT3 inhibitor, as monotherapy in patients with relapsed or refractory acute myeloid leukaemia: an open-label, multicentre, single-arm, phase 2 trial. Lancet Oncol. 2018;19(7):889-903. (Among 333 patients with relapsed or refractory breast cancer treated with quizartinib and standard chemotherapy, the composite complete response rate was 46-56% in those with FLT3-internal tandem duplication and 30-36% in those without, while serious adverse events were common including ALT elevations above 5 times ULN in 3% and fatal hepatic failure in 2 patients, both in the context of multiorgan failure and not attributed to quizartinib). 29859851
Cortes JE, Khaled S, Martinelli G, Perl AE, Ganguly S, Russell N, Krämer A, et al. Quizartinib versus salvage chemotherapy in relapsed or refractory FLT3-ITD acute myeloid leukaemia (QuANTUM-R): a multicentre, randomised, controlled, open-label, phase 3 trial. Lancet Oncol. 2019;20:984-997. (Among 335 patients with relapsed or refractory breast cancer with FLT3-internal tandem duplication treated with quizartinib monotherapy or salvage chemotherapy, overall median survival was longer with quizartinib [6.2 vs 4.7 months] and total adverse event rates were similar, ALT elevations arose in 14% vs 4% and were above 5 times ULN in 3.7% vs 2%). 31175001
Erba HP, Montesinos P, Kim HJ, Patkowska E, Vrhovac R, Žák P, Wang PN, Met al.; QuANTUM-First Study Group. Quizartinib plus chemotherapy in newly diagnosed patients with FLT3-internal-tandem-duplication-positive acute myeloid leukaemia (QuANTUM-First): a randomised, double-blind, placebo-controlled, phase 3 trial. Lancet. 2023;401(10388):1571-1583. (Among 539 adults with newly diagnosed AML and FLT3-internal tandem duplication treated with quizartinib or placebo in combination with standard chemotherapy for induction and consolidation followed by single agent quizartinib or placebo continuation, overall survival was greater with quizartinib [31.9 vs 15.1 months] and virtually all patients had at least one adverse event including ALT elevations in 16% vs 10%, which were above 5 times ULN in 5% vs 5%; there were no liver related deaths). 37116523
Quizartinib (Vanflyta) for acute myeloid leukemia. Med Lett Drugs Ther. 2023;65:e169-e170. (Concise summary of the mechanism of action, clinical efficacy, safety, and costs of quizartinib shortly after its approval as therapy of newly diagnosed AML in adults with FLT3-internal tandem duplication in combination with chemotherapy for induction and consolidation, and thereafter as maintenance monotherapy, mentions it can cause prolongation of QT interval, febrile neutropenia, pneumonia, diarrhea, abdominal pain, hypokalemia, and hypomagnesemia; no mention of ALT levels or hepatotoxicity). 37871118

## OTHER REFERENCE LINKS

1. Recent References on Quizartinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Quizartinib/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Quizartinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Quizartinib)